# Methadone

## OVERVIEW

### Introduction

Methadone is a synthetic opioid which is used widely as an analgesic as well as maintenance therapy for persons with opioid dependency. Patients on chronic methadone therapy for opioid dependency often have underlying chronic viral hepatitis, but methadone itself has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Methadone (meth’ a done) is a fully synthetic, long acting opioid that has similar, but not fully equal potency to morphine, although somewhat different pharmacokinetics and clinical effects. Methadone, like other opioids, acts by engagement in cell surface opiate receptors (predominant µ type receptors) that are found in the central nervous system, but also heart, lung, vascular and intestinal cells. Methadone may also act as an antagonist of the N-methyl-D-aspartate (NMDA) receptor accounting for some of its different effects. Methadone is a full opiate agonist and is well absorbed orally and has a longer half-life than morphine, features that can be used to help stabilize patients with opiate dependency by preventing withdrawal symptoms. In addition, the withdrawal syndrome from methadone is slower in onset, more prolonged and less severe than that with morphine. Methadone was first approved for use as an opioid analgesic in the United States in 1947. Since then, its indications have expanded and now include management of acute or chronic moderate-to-severe pain not responsive to nonnarcotic analgesics, detoxification of opioid dependency and maintenance treatment of opioid addiction. Methadone is available generically and under the brand names Dolophine and Methadose among others, in tablets of 5, 10 and 40 mg, oral solutions of 5 and 10 mg/5 mL (and concentrate of 10 mg/mL), and as a solution for injection in concentrations of 10 mg/mL. Typical oral doses vary by indication and clinical response. For opiate abstinence syndrome the dose is highly individualized, but maintenance doses are generally in the range of 20 to 120 mg daily. Side effects include sedation, respiratory depression, confusion, euphoria, agitation, itching, sweating, abdominal bloating, nausea, vomiting and constipation, adverse effects which are typical of the opioids. Methadone is a controlled substance and classified as a Schedule II drug, indicating that it has medical usefulness, but also a high potential for physical and psychological dependency and abuse. Use of methadone as a part of an opiate abstinence program requires special certification.

### Hepatotoxicity

Therapy with methadone has not been linked to serum enzyme elevations or to idiosyncratic acute, clinically apparent liver injury. However, chronic hepatitis B and C are common among persons on methadone maintenance. There is no evidence that methadone maintenance worsens the course of chronic viral hepatitis. In prospective studies, transient serum enzyme elevations were not uncommon in patients on methadone maintenance; however, almost all of the abnormalities occurred in patients with underlying chronic hepatitis B or C and no clinically apparent liver injury arose anew during therapy.

References on the safety and potential hepatotoxicity of methadone are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Methadone – Generic, Dolophine®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Methadone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Methadone | 76-99-3 | C21-H27-N-O | Methadone Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Methadone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Methadone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Methadone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Methadone)